# Denileukin Diftitox

## OVERVIEW

### Introduction

Denileukin diftitox is a recombinant fusion protein of human interleukin-2 (IL-2) attached to diphtheria toxin fragments A and B that is used as an antineoplastic agent to treat cutaneous T cell lymphomas that express IL-2 receptors. High doses of denileukin diftitox can cause mild-to-moderate elevations in serum enzymes and bilirubin, but rarely result in clinically significant acute liver injury.

### Background

Denileukin (den" i loo' kin) diftitox (dif' ti tox) is a fusion protein that combines human interleukin-2 (IL-2) with diphtheria toxin fragments A and B. Denileukin diftitox was approved for use in the United States in 1999 and the indications remain limited to therapy of refractory cutaneous T cell lymphomas that express the CD25 component of the IL-2 receptor on the surface of the malignant cells. Once taken up by the cells expressing the IL-2 receptor, the diphtheria toxin is released into the cytoplasm causing cell death. Denileukin diftitox is available in solution in 2 mL single use vials of 150 µg/mL under the brand name Ontak. The typical dose is 9 to 18 µg/kg given intravenously once daily for 5 consecutive days every 21 days for up to 8 cycles. Side effects are common with denileukin diftitox therapy, and it should be administered in a hospital setting under the supervision of physicians experienced in the use of anticancer agents. Common side effects include fatigue, fever, chills, nausea, diarrhea, arthralgia, headache and rash. Up to 25% of patients develop capillary leak syndrome leading to peripheral edema, hypotension and renal insufficiency and can cause shock, pulmonary edema, renal failure and death. Less common but potentially severe adverse reactions include anaphylaxis, severe infections, thrombotic events and pancreatitis.

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations in occurred in 61% of patients treated with denileukin diftitox, and values were above 5 times the upper limit of normal (ULN) in 15% of recipients. Hypoalbuminemia (less than 3.0 g/dL) was also common during treatment, occurring in 83% of patients but falling to less than 2.0 g/dL in only 14%. However, clinically apparent liver injury with jaundice was not reported in these trials. Since approval of denileukin diftitox there have not been reports of acute liver injury with jaundice associated with its administration, although it has had quite limited clinical use. Thus, denileukin diftitox has been clearly linked to serum enzyme elevations and hypoalbuminemia during treatment, but has not been implicated in cases of idiosyncratic, acute liver injury with jaundice.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which denileukin diftitox infusions causes liver injury is not well defined, but it is likely taken up by hepatocytes to some degree and might have a direct toxic effect on liver cells. As it is a recombinant human protein, it is unlikely to have direct intrinsic hepatotoxicity.

### Outcome and Management

The serum enzyme and bilirubin elevations during denileukin diftitox therapy are generally asymptomatic, self-limited and benign. In situations in which ALT or AST levels rise and remain above 5 times ULN, dose modification or temporary discontinuation of the intravenous infusions is prudent.

Drug Class: Antineoplastic Agents, Cytokines, Biologic Response Modifiers

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Denileukin Diftitox – Ontak®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Denileukin%20Diftitox)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Denileukin Diftitox | 173146-27-5 | Cytokine | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 27 December 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of denileukin diftitox).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Interleukin-2. Med Lett Drugs Ther 1990; 32 (826): 85-6. (Concise summary of the mechanism of action, clinical efficacy and safety of recombinant IL-2 mentions side effects of increased capillary permeability with fluid retention, hypotension, renal insufficiency and pulmonary edema as well as severe malaise, fever, nausea, diarrhea, anemia and hyperbilirubinemia). 2202892
Olsen E, Duvic M, Frankel A, Kim Y, Martin A, Vonderheid E, Jegasothy B, et al. Pivotal phase III trial of two dose levels of denileukin diftitox for the treatment of cutaneous T-cell lymphoma. J Clin Oncol 2001; 19: 376-88. (Among 71 patients with refractory cutaneous T cell lymphoma treated with denileukin diftitox [9 or 18 µg/kg] daily for 5 days every 3 weeks for up to 8 cycles, 30% had a partial or complete response with no differences in the two doses; 61% of patients had elevations in serum ALT or AST, which were above 5 times ULN in 17%). 11208829
Dang NH, Hagemeister FB, Pro B, McLaughlin P, Romaguera JE, Jones D, Samuels B, et al. Phase II study of denileukin diftitox for relapsed/refractory B-Cell non-Hodgkin's lymphoma. J Clin Oncol 2004; 22: 4095-102. (Among 45 patients with refractory non-Hodgkin lymphoma treated with denileukin diftitox, partial or complete responses occurred in 24% and "overall treatment was well tolerated" with ALT or AST elevations above 5 times ULN in 17 [38%] patients, and toxic epidermal necrosis and capillary leak syndrome in 1 patient each). 15353540
Frankel AE, Surendranathan A, Black JH, White A, Ganjoo K, Cripe LD. Phase II clinical studies of denileukin diftitox diphtheria toxin fusion protein in patients with previously treated chronic lymphocytic leukemia. Cancer 2006; 106: 2158-64. (Among 22 patients with refractory chronic lymphocytic leukemia treated with denileukin diftitox, 6 [27%] had an objective response and "toxicities were moderate", 32% of patients having ALT or AST elevations above 5 times ULN and 14% vascular leak syndrome, but none required stopping therapy for liver injury). 16586495
Gerena-Lewis M, Crawford J, Bonomi P, Maddox AM, Hainsworth J, McCune DE, Shukla R, et al. A Phase II trial of Denileukin Diftitox in patients with previously treated advanced non-small cell lung cancer. Am J Clin Oncol 2009; 32: 269-73. (Among 41 patients with advanced non-small cell lung cancer treated with 1 to 6 cycles of denileukin diftitox [18 µg/kg daily for 5 days], none had an objective response, 22% developed ALT or AST levels [all less than 5 times ULN], 5 had vascular leak syndrome and 1 died of drug related myocarditis). 19433964
Prince HM, Duvic M, Martin A, Sterry W, Assaf C, Sun Y, Straus D, et al. Phase III placebo-controlled trial of denileukin diftitox for patients with cutaneous T-cell lymphoma. J Clin Oncol 2010; 28: 1870-7. (Among 144 patients with refractory cutaneous T-cell lymphomas [CD25 positive] treated with denileukin diftitox [9 or 18 µg/kg daily for 5 days] or placebo infusions every 21 days for up to 8 cycles, objective responses occurred in 44% of those on drug vs 16% on placebo while "continued treatment did not cause worsening of laboratory parameters and was not associated with liver or renal toxicity"). 20212249
Duvic M, Martin AG, Olsen EA, Fivenson DP, Prince HM. Efficacy and safety of denileukin diftitox retreatment in patients with relapsed cutaneous T-cell lymphoma. Leuk Lymphoma 2013; 54: 514-9. (Among 20 patients with cutaneous T cell lymphomas who relapsed after previous therapy with denileukin diftitox and who were then retreated with up to 8 cycles [18 µg/kg daily for 5 days], 40% had an objective response while 55% had serious adverse events, but none died or had severe capillary leak syndrome; no mention of ALT elevations or hepatotoxicity). 22891708
Baldo BA. Chimeric fusion proteins used for therapy: indications, mechanisms, and safety. Drug Saf 2015; 38: 455-79. (Review of the mechanism of action, efficacy and safety of therapeutic recombinant fusion proteins mentions that serious adverse reactions to denileukin diftitox include infusion and hypersensitivity reactions, skin rash, [including toxic epidermal necrolysis], capillary leak syndrome, shock, renal insufficiency, decreased vision and infections; no discussion of ALT elevations or hepatotoxicity). 25832756
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, recombinant fusion proteins accounted for only 2 cases [both etanercept], and none were linked to abatacept, alefacept, rilonacept, romiplostim or denileukin-diftitox). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Denileukin Diftitox: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Denileukin%20Diftitox/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Denileukin Diftitox: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Denileukin%20Diftitox)